# Capivasertib

## OVERVIEW

### Introduction

Capivasertib is a small molecule inhibitor of serine/threonine kinase 1, 2 and 3 and is used in combination with other antineoplastic agents to treat selected adults with locally advanced or metastatic breast cancer. Capivasertib is associated with transient elevations in serum aminotransferase levels during therapy but has not been linked to episodes of clinically apparent liver injury with jaundice.

### Background

Capivasertib (kap eye” va ser’ tib) is an orally available, specific inhibitor of all three isoforms of serine/threonine kinase (AKT1, AKT2, and AKT3) that is used in combination with fulvestrant in the therapy of advanced or metastatic breast cancer with one or more mutations or alterations in AKT, the phosphatidylinositol 3 kinase catalytic alpha subunit p110α (PIK3-CA), or the phosphatase and tensin homolog (PTEN) and is positive for hormone receptor (HR) and negative for human epidermal growth factor receptor 2 (HER2). At least one of these three mutated genes is found in a large proportion of cases of refractory, advanced or metastatic HR-positive breast cancer. PIK3 and PTEN are downstream signaling pathways of AKT and thus are inhibited if AKT isomers are blocked. In cell lines, capivasertib induced apoptosis in PIK3-CA, AKT, and PTEN mutated breast cancer cell lines and demonstrated antitumor activity in animal xenograft models of these mutated breast cancers. In a large, controlled trial, patients with HR-positive and HER2-negative advanced or metastatic breast cancer harboring one or more of these mutations were treated with fulvestrant combined with either capivasertib or placebo in 28 day cycles. The median progression-free survival was superior with capivasertib [7.2 months] compared to placebo [3.6 months]. Capivasertib was approved in 2023 in the United States as treatment for patients with locally advanced or metastatic HR-positive, HER2-negative breast cancer with mutations in PIK3-CA, AKT or PTEN. Capivasertib is available in tablets of 160 and 200 mg under the brand name Truqap. The recommended dose is 400 mg twice daily for 4 days followed by 3 days off, continuing until unacceptable toxicity or disease progression. Side effects are common and include mild-to-moderate diarrhea, fatigue, nausea, vomiting, stomatitis, and rash. Laboratory abnormalities can include increases in fasting and random glucose levels, creatinine, and triglycerides, as well as decreases in neutrophils, lymphocytes, and hemoglobin. Less frequent but potentially severe adverse events include severe hyperglycemia, rash, diarrhea, and embryo-fetal toxicity.

### Hepatotoxicity

In the prelicensure trials of capivasertib in combination with fulvestrant as therapy of advanced or metastatic breast cancer, liver test abnormalities were frequent, with elevations in ALT levels in 23% compared to 13% of those on placebo and fulvestrant. However, the enzyme elevations were usually transient, mild-to-moderate in severity and not associated with symptoms or jaundice. ALT elevations above 5 times the upper limit of normal (ULN) arose in 3% of patients on capivasertib vs 0% with placebo. Because capivasertib was always given in combination with a hormonal agent, it was not always possible to attribute the liver test abnormalities to capivasertib alone. There were no discontinuations of capivasertib because of liver test abnormalities and no episodes of clinically apparent liver injury or deaths from liver failure. Since approval and clinical availability of capivasertib, there have been no published case reports of clinically apparent liver injury with jaundice, but clinical experience with its use has been limited.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

The causes of serum enzyme elevations or liver injury from capivasertib therapy are possibly due to direct toxicity of the multi-kinase inhibitor. Capivasertib is primarily metabolized in the liver by the hepatic microsomal enzyme CYP3A4. For this reason, inhibitors of CYP3A can increase capivasertib exposure, possibly increasing its toxicity, and inducers of CYP3A can decrease capivasertib exposure, possibly decreasing efficacy. For these reasons, use of concomitant CYP3A inhibitors or inducers while using capivasertib should be avoided, and dose adjustments may be needed if they are considered necessary.

### Outcome and Management

The product label for capivasertib does not recommend monitoring of liver tests during therapy. If serum aminotransferase elevations above 5 times the upper limit of normal are identified or if any elevations are accompanied by jaundice or symptoms, therapy should be at least temporarily discontinued until the cause is apparent. There is no evidence to suggest a cross reactivity in risk for adverse events, hypersensitivity, or hepatic injury between capivasertib and other kinase inhibitors used to treat breast cancer, such as palbociclib, ribociclib, alpelisib, and inavolisib.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

Other Kinase Inhibitors Used for Breast Cancer: Alpelisib, Inavolisib, Ribociclib, Talazoparib, Tucatinib

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Capivasertib – Truqap®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Capivasertib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Capivasertib | 1143532-39-1 | C21-H25-ClN6-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 05 April 2025

Abbreviations: AKT, serine/threonine kinase; HER2, human epidermal growth factor receptor 2; HR, hormone receptor; PIK3, phosphatidylinositol-3-kinase; PIK3-CA, PIK3 catalytic alpha subunit p110α; PTEN, phosphatase and tensin homolog; ULN, upper limit of the normal range.

Zimmerman HJ. Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of tyrosine kinase inhibitors such as capivasertib).
DeLeve LD. Erlotinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents discusses several tyrosine kinase inhibitors including imatinib, gefitinib, erlotinib and crizotinib, but not capivasertib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. Multi-Discipline Review. 2023. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2023/218197Orig1s000MultidisciplineR.pdf (FDA review of the data on efficacy and safety of capivasertib in support of its approval for advanced or metastatic breast cancer in the US, mentions that liver test abnormalities were frequent in the patients who received capivasertib and fulvestrant vs placebo and fulvestrant, ALT elevations arising in 23% vs 13% which were above 5 times the upper limit of normal (ULN) in 3% vs 0%, but that there were no instances of clinically apparent liver injury with jaundice or life-threatening or fatal liver injury).
Spraggs CF, Xu CF, Hunt CM. Genetic characterization to improve interpretation and clinical management of hepatotoxicity caused by tyrosine kinase inhibitors. Pharmacogenomics 2013; 14: 541-54. (Review of genetic associations of serum ALT and bilirubin elevations during therapy with tyrosine kinase inhibitors focusing on lapatinib and pazopanib; capivasertib is not discussed). 23556451
Shah RR, Morganroth J, Shah DR. Hepatotoxicity of tyrosine kinase inhibitors: clinical and regulatory perspectives. Drug Saf 2013; 36: 491-503. (Review of the hepatotoxicity of 18 tyrosine kinase inhibitors approved for use in cancer in the US as of 2013, before the availability of capivasertib which is not discussed). 23620168
Schmid P, Abraham J, Chan S, Wheatley D, Brunt AM, Nemsadze G, Baird RD, Park YH, et al. Capivasertib plus paclitaxel versus placebo plus paclitaxel as first-line therapy for metastatic triple-negative breast cancer: the PAKT trial. J Clin Oncol. 2020;38:423-433. (Among 140 women with triple negative, metastatic breast cancer treated with paclitaxel and either capivasertib or placebo, progression-free survival was 5.9 vs 4.2 months (but was 9.3 vs 3.7 months in the 28 patients with mutations in PIK3-CA, AKT, or PTEN); adverse events arose in 97% vs 91% and were severe in 54% vs 26% of participants, which were most frequently diarrhea, fatigue, rash, infection, and neutropenia; no mention of ALT elevations or hepatotoxicity). 31841354
Turner NC, Oliveira M, Howell SJ, Dalenc F, Cortes J, Gomez Moreno HL, Hu X, et al.; CAPItello-291 Study Group. Capivasertib in hormone receptor-positive advanced breast cancer. N Engl J Med. 2023;388:2058-2070. (Among 708 adults with HR-positive, HER2-negative refractory, advanced or metastatic breast cancer treated with fulvestrant and either capivasertib or placebo, progression-free survival was 7.2 vs 3.6 months, and adverse events arose in most patients and were severe in 16% vs 8%, the most frequent adverse events being diarrhea [72% vs 20%], nausea [35% vs 15%], and severe rash [12% vs 13%]; adverse events leading to discontinuation in 13% vs 2.3%; no mention of ALT elevations or hepatotoxicity). 37256976
Capivasertib (Truqap) for breast cancer. Med Lett Drugs Ther. 2024;66:e32-e33. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of capivasertib shortly after its approval for use in breast cancer in the US mentions that diarrhea is the most frequent adverse event and that nausea, fatigue, vomiting, stomatitis, cutaneous adverse reactions, cytopenias, and hyperglycemia have been reported; no mention of ALT elevations or hepatotoxicity). 38412269
Rugo HS, Oliveira M, Howell SJ, Dalenc F, Cortes J, Gomez HL, Hu X, et al. Capivasertib and fulvestrant for patients with hormone receptor-positive advanced breast cancer: characterization, time course, and management of frequent adverse events from the phase III CAPItello-291 study. ESMO Open. 2024;9:103697. (Review of the most frequent adverse events identified in the large, randomized, placebo-controlled trial of capivasertib given in combination with fulvestrant for patients with advanced breast cancer discusses diarrhea, rash, and hyperglycemia in detail; no mention of ALT elevations or hepatotoxicity). 39241495
Dilawari A, Buturla J, Osgood C, Gao X, Chen W, Ricks TK, Schaefer T, et al. US Food and Drug Administration approval summary: capivasertib with fulvestrant for hormone receptor-positive, human epidermal growth factor receptor 2-negative locally advanced or metastatic breast cancer with PIK3CA/AKT1/PTEN alterations. J Clin Oncol. 2024;42:4103-4113. (Summary of the data on efficacy and safety of capivasertib that supported its approval by the FDA as therapy of HR-positive, HER2 negative advanced breast cancer with alterations in PIK3CA, AKT1, or PTEN, discusses the major adverse events but does not mention ALT elevations or hepatotoxicity). 39159418

## OTHER REFERENCE LINKS

1. Recent References on Capivasertib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Capivasertib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Capivasertib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Capivasertib)